# Fostemsavir

## OVERVIEW

### Introduction

Fostemsavir is a unique antiretroviral agent that binds to an envelope antigen of the human immunodeficiency virus (HIV) inhibiting its attachment to cell surface receptors of CD4+ lymphocytes. It is used to treat patients with multidrug resistant infection and inadequate viral suppression despite optimized background therapy. Fostemsavir has been linked to a low rate of serum aminotransferase elevations during therapy but has not been linked convincingly to episodes of clinically apparent liver injury.

### Background

Fostemsavir (fos tem’ sa vir) is a unique antiretroviral drug that binds the gp120 subunit of the HIV envelope protein that mediates viral attachment to cell surface receptors on CD4+ lymphocytes, an initial and necessary step in HIV replication. Fostemsavir has both in vitro and in vivo activity against HIV and was developed as an adjunctive therapy for heavily treatment-experienced patients with multidrug antiviral resistance who had failed to achieve adequate viral suppression on a potent antiretroviral regimen. In large, long term, open label studies, the addition of fostemsavir to an optimized background regimen of antiretroviral agents resulted in full viral suppression (less than 50 HIV RNA copies per mL) in 38% to 54% of patients, with accompanying improvements in peripheral CD4 counts. Fostemsavir was approved as therapy of adults with multidrug-resistant HIV infection in the United States in 2020, but only in combination with other antiretroviral agents. Fostemsavir is available in tablets of 600 mg under the brand name Rukobia. The recommended dose is 600 mg twice daily. Common side effects include nausea, diarrhea, headache, abdominal pain, dyspnea, fatigue, itching, rash, sleep disturbance, and somnolence. Less common but potentially severe adverse events include immune reconstitution syndrome, QTc prolongation, peripheral neuropathy and worsening of chronic coinfection with hepatitis B or C virus.

### Hepatotoxicity

In registration clinical trials, fostemsavir was associated with alanine aminotransferase (ALT) elevations in up to 25% of patients, but levels above 5 times the upper limit of normal (ULN) arose in only 4% of subjects. Most ALT elevations were transient, asymptomatic, and did not require dose modification or discontinuation. The more marked ALT elevations were usually attributable to other conditions or complications of HIV infection. No convincing cases of fostemsavir induced liver injury were observed in preregistration trials. Since approval of fostemsavir for use as a part of a multidrug therapy of HIV, there have been no published case reports of clinically apparent liver injury attributed to its use.

Interestingly, in the large preregistration trial of fostemsavir, elevations in serum aminotransferase levels were particularly noted in patients with coinfection with either hepatitis B virus (HBV) or hepatitis C virus (HCV). The deaths from liver disease in this trial appeared to be due to worsening of the coinfection during therapy. Clearly, patients with HBV or HCV coinfection should be treated for those viral infections before or concurrent with antiretroviral therapy with fostemsavir.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Fostemsavir is metabolized predominantly by esterase mediated hydrolysis and to a lesser extent by hepatic microsomal enzymes, predominantly CYP 3A4. Strong inducers of CYP 3A4 have the potential of lowering levels of fostemsavir and should be avoided if possible.

### Outcome and Management

Serum enzyme elevations during fostemsavir therapy are generally transient, mild-to-moderate in severity, and often attributable to other causes. Because of the complexity of therapy for multidrug resistant HIV infection, caution should be used in altering the dose or discontinuation of fostemsavir unless the adverse events is clearly due to the gp120 attachment inhibitor.

Drug Class: Antiviral Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fostemsavir – Rukobia®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fostemsavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fostemsavir | 864953-29-7 | C25-H26-N7-O8-P

## ANNOTATED BIBLIOGRAPHY

References updated: 20 June 2023

Abbreviations: HBV, hepatitis B virus; HCV, hepatitis C virus; HIV, human immunodeficiency virus.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents does not include fostemsavir or gp120 attachment inhibitors).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-57. (Textbook of pharmacology and therapeutics).
https://hivinfo.nih.gov/hiv-source/medical-practice-guidelines/hiv-treatment-guidelines (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
FDA: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212950Orig1s000TOC.cfm (FDA website with product labels and the integrated review of the data submitted in support of the approval of fostemsavir, mentions among 371 adults with multidrug resistant HIV infection treated with fostemsavir, ALT elevations arose in 91 patients [25%] that rose above 5 times ULN in 15 [4%] and were associated with jaundice in 6, but most events could be attributed to other diagnoses and “There is no clear evidence of fostemsavir induced liver injury”, several cases of liver injury being flares of hepatitis B due to withdrawal of antiretroviral drugs with HBV activity and some being due to progression of concurrent chronic hepatitis C).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were due to antiretroviral agents, but none were attributed to fostemsavir).
Thompson M, Lalezari JP, Kaplan R, Pinedo Y, Pena OAS, Cahn P, Stock DA, et al. (2017). AI438011 study team. Safety and efficacy of the HIV-1 attachment inhibitor prodrug fostemsavir in antiretroviral-experienced subjects: week 48 analysis of AI438011, a Phase IIb, randomized controlled trial. Antivir Ther. (Among 251 adults with treatment-experienced HIV infection receiving tenofovir and raltegravir who had persistence of HIV RNA levels above 1000 copies/mL and were treated with fostemsavir [in 4 different dose regimens] vs atazanavir/ritonavir, suppression of HIV RNA to less than 50 copies/mL was achieved in 69-91% of those on fostemsavir vs 88% on atazanavir, and adverse event rates were similar, ALT elevations above 5 times ULN arising only with the once daily 1200 mg dose of fostemsavir [4%] and with no cases of liver injury with jaundice).
Markham A. (2020). Fostemsavir: first approval. Drugs. (Review of the chemical structure, mechanism of action, history of development, clinical efficacy and safety of fostemsavir, a prodrug of temsavir which binds to the gp120 subunit of the HIV envelope protein, blocking its attachment to CD4+ lymphocyte cell surface receptors, mentions that ALT elevations above 5 times ULN arose in 5% and bilirubin levels above 2.5 mg/dL in 7% of treated patients, but does not mention occurrence or rates of clinically apparent liver injury).
Kozal M, Aberg J, Pialoux G, Cahn P, Thompson M, Molina JM, Grinsztejn B, et al., BRIGHTE Trial Team. (2020). Fostemsavir in adults with multidrug-resistant HIV-1 infection. N Engl J Med. (Among 371 adults with multidrug resistant HIV infection treated with optimized background therapy and addition of fostemsavir [600 mg twice daily] for 48 weeks, suppression of HIV RNA to less than 40 copies/mL was achieved in 38-54% of patients, while the total adverse event rate was 90%, serious adverse event rate 35%, and mortality rate 7%: 2 of the 25 deaths were from hepatic failure – one due to flare of hepatitis B and one to progression of chronic hepatic C; ALT elevations above 5 times ULN occurred in 11 patients [3%] and led to drug discontinuation in 3 patients including the 2 who died).
Lataillade M, Lalezari JP, Kozal M, Aberg JA, Pialoux G, Cahn P, Thompson M, et al. (2020). Safety and efficacy of the HIV-1 attachment inhibitor prodrug fostemsavir in heavily treatment-experienced individuals: week 96 results of the phase 3 BRIGHTE study. Lancet HIV. (In a further follow up of the phase 3 trial of fostemsavir in 371 adults with multidrug resistant HIV infection [Kozal 2020], the rate of successful viral suppression was sustained from week 48 to 96 and CD4 lymphocyte counts continued to increase, while no new adverse events were observed; no mention of ALT elevations or further hepatic events).
Rivera CG, Otto AO, Zeuli JD, Temesgen Z. (2021). Hepatotoxicity of contemporary antiretroviral drugs. Curr Opin HIV AIDS. (Review of the hepatotoxicity of drugs approved for treatment of HIV infection in the US, mentions that fostemsavir had no episodes of discontinuation for drug induced liver injury, but that ALT elevations above 5 times ULN arose in 4% of treated patients and resulted in discontinuation in 4 subjects, the liver injury in each case was attributed to other causes).
Ackerman P, Thompson M, Molina JM, Aberg J, Cassetti I, Kozal M, Castagna A, et al. (2021). Long-term efficacy and safety of fostemsavir among subgroups of heavily treatment-experienced adults with HIV-1. AIDS. (Further analysis of the phase 3 trial of fostemsavir in 371 patients with multidrug resistant HIV infection [Koval 020] demonstrated virologic responses observed at 24 weeks were maintained long term (to week 96] with gradual increase in CD4 lymphocyte counts overall, and that higher response rates and fewer adverse events occurred among patients with higher baseline CD4 counts and lower baseline HIV RNA levels; no mention of hepatic adverse events or ALT levels).

## OTHER REFERENCE LINKS

1 Recent References on Fostemsavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fostemsavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fostemsavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fostemsavir)